# Vardenafil

## OVERVIEW

### Introduction

Vardenafil is a selective inhibitor of phosphodiesterase type 5 (PDE5) and is used as therapy of erectile dysfunction. Vardenafil has not been associated with serum aminotransferase elevations nor with clinically apparent liver injury.

### Background

Vardenafil (var den' a fil) is a selective inhibitor of phosphodiesterase type 5 (PDE5), an intracellular enzyme that mediates the breakdown of cyclic guanosine monophosphate (cGMP) inducing smooth muscle relaxation in the corpus cavernosum of the penis and in the pulmonary vasculature where this specific phosphodiesterase is found. Vardenafil is effective in prolonging erection and was approved for use in the United States in 2003. Vardenafil is available in tablets of 2.5, 5, 10 and 20 mg under the brand name of Levitra and as 10 mg oral disintegrating tablets under the brand name of Staxyn. The recommended dose is 10 mg as a single dose as needed one hour before sexual activity. The dose of the standard oral tablet can be increased or decreased based upon effect and tolerance, with a recommended maximum frequency of once daily and maximum dosage of 20 mg. Common side effects include dizziness, headache, flushing, hypotension, rhinitis and dyspepsia. Rare, but potentially serious adverse events include vision and hearing loss, hypotension, cardiovascular events and priapism.

### Hepatotoxicity

Despite fairly extensive use, vardenafil has not been associated with clinically apparent cases of liver injury and serum enzyme elevations during therapy are rare. The related PDE5 inhibitors, sildenafil and tadalafil have been linked to isolated, rare instances of acute liver injury and jaundice. The latency to onset ranged from a few days to 3 months and the pattern of injury was usually cholestatic. Autoimmune and immunoallergic features were not observed and all cases were self-limited without residual injury or acute liver failure. Whether vardenafil can cause a similar form of acute liver injury is unknown.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

While vardenafil has not been associated with hepatotoxicity, its potential for causing hypotension and use in patients with cardiac disease may lead to instances of acute ischemic liver injury. Vardenafil, like the other PDE5 inhibitors, is metabolized in the liver via the cytochrome P450 system (CYP 3A4).

### Outcome and Management

While sildenafil and tadalafil have been linked to rare instances of clinically apparent acute liver injury, vardenafil has not. There is no known cross sensitivity in idiosyncratic adverse effects between vardenafil and the other PDE5 inhibitors currently in use in the United States. However, switching to another PDE5 inhibitor after an episode of clinically apparent liver injury should be done with caution.

References to vardenafil induced liver injury are provided in the Overview section on PDE5 Inhibitors.

Drug Class: PDE5 Inhibitors

Other Drugs in the Class: Avanafil, Sildenafil, Tadalafil

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Vardenafil – Levitra®

DRUG CLASS

PDE5 Inhibitors

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=vardenafil)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Vardenafil | 224785-90-4 | C23-H32-N6-O4-S | Vardenafil chemical structure

## OTHER REFERENCE LINKS

1. Recent References on Vardenafil: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=vardenafil+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Vardenafil: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=vardenafil)